# Nicotine

## OVERVIEW

### Introduction

Nicotine is a natural alkyloid that is a major component of cigarettes and is used therapeutically to help with smoking cessation. Nicotine has not been associated with liver test abnormalities or with clinically apparent hepatotoxicity.

### Background

Nicotine (nik' oh teen) is a liquid alkyloid that has a variety of activities in the body and central nervous system (CNS), acting largely as a stimulant via activation of nicotinic receptors. Nicotine is a CNS stimulant and has both stimulatory and depressant actions on autonomic ganglia. Nicotine has multiple actions including CNS stimulation, elation, wakefulness and appetite suppression. It also causes dependency and addiction accounting for the difficulty of smoking cessation. Indeed, the major medical use of nicotine is to help to stop smoking. Oral and transdermal forms of nicotine have been shown to increase the rate of smoking cessation. Nicotine is readily absorbed through the skin, mucous membranes and lungs. Oral nicotine can be taken as a gum (Nicorette: 2 or 4 mg each), or lozenge (2 or 4 mg) which is dissolved in the mouth and not swallowed or chewed. Nasal spray, inhaler (Nicotrol) and transdermal formulations (NicoDerm, Habitrol and others) are also used in smoking cessation programs. Most of these products are available over the counter, without prescription. The usual dose regimen varies by formulation and the dose is typically given in decreasing amounts with cigarette withdrawal. Cigarettes typically have 10 to 25 mg of nicotine each, and peak plasma nicotine levels are higher with cigarettes than with replacement products. Common side effects of nicotine include nausea, dyspepsia, nervousness, dizziness, headache, tachycardia and palpitations. Overdose of nicotine can cause mental confusion, faintness, hypotension, convulsions and respiratory failure.

Starting in 2006, electronic nicotine delivery systems (e-cigarettes) became available in the United States. The typical e-cigarette includes a lithium battery, a heating coil and a solute chamber that contains a liquid solution of nicotine typically suspended in propylene glycol with flavors and other ingredients. The heating coil creates a nicotine vapor (and thus called “vaping”) that is inhaled through a mouthpiece. E-cigarettes were promoted as a means of smoking cessation, but in prospective controlled trials they were only minimally more effective than conventional nicotine replacement or other pharmacological therapies. Furthermore, the majority of subjects who were able to stop smoking by using e-cigarettes continued vaping use long term, thus serving as a smoking replacement. While e-cigarettes have been shown to contain fewer and less potential harmful compounds, they cannot be considered entirely safe. Furthermore, many individuals and particularly teenagers who have not previously smoked have begun vaping and often using flavored or cannabinoid based products. While e-cigarettes have fewer adverse effects than conventional cigarettes, they have been linked to rare but potentially severe adverse events include vaping associated lung injury that appears to be caused by use of vitamin E acetate as a solvent for nicotine and cannabinoid solutions.

### Hepatotoxicity

Nicotine used in cigarette cessation programs as well as nicotine containing e-cigarettes have not been associated with serum enzyme elevations during therapy at rates greater than occurred with placebo. Medical and recreational uses of nicotine have not been associated with cases of clinically apparent liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Nicotine is metabolized extensively by many tissues including the liver and is rapidly excreted.

[Agents in clinical use to aid in smoking cessation and to treat nicotine withdrawal symptoms include bupropion, nicotine, and varenicline.]

Drug Class: Substance Abuse Treatment Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nicotine – Generic, Commit®, Nicorette® (Oral); Habitrol® (Transdermal); Nicotrol® (Inhaler, Spray)

DRUG CLASS

Substance Abuse Treatment Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Nicotine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Nicotine | 54-11-5 | C10-H14-N2

## ANNOTATED BIBLIOGRAPHY

References updated: 25 March 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999; nicotine is not discussed).
Hibbs RE, Zambon AC. Nicotine. Agents acting at the neuromuscular junction and autonomic ganglia. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp 177-90. (Textbook of pharmacology and therapeutics).
O'Brien CP. Nicotine. Drug addiction and drug abuse. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp 437-9. (Textbook of pharmacology and therapeutics).
Molyneux A. (2004). Nicotine replacement therapy. BMJ. (Review of nicotine replacement therapy including mechanism of action, evidence of effectiveness, formulations, and safety; choice of product should be by patient preference; the products are safer than cigarettes and the only safety concerns relate to pregnant women and patients with heart disease).
Marsh HS, Dresler CM, Choi JH, Targett DA, Gamble ML, Strahs KR. (2005). Safety profile of a nicotine lozenge compared with that of nicotine gum in adult smokers with underlying medical conditions: a 12-week, randomized, open-label study. Clin Ther. (901 smokers with other medical conditions [mostly heart disease and diabetes] were treated with nicotine gum or lozenges for 12 weeks; nausea, hiccups and headache were the most common side effects; no mention of hepatotoxicity, but no instances of acute liver injury).
Dautzenberg B, Nides M, Kienzler JL, Callens A. (2007). Pharmacokinetics, safety and efficacy from randomized controlled trials of 1 and 2 mg nicotine bitartrate lozenges (Nicotinell). BMC Clin Pharmacol. (Use of nicotine lozenges even in higher than recommended amounts was not associated with any "clinically significant changes" in serum enzyme levels).
Shiffman S, Sweeney CT. (2008). Ten years after the Rx-to-OTC switch of nicotine replacement therapy: what have we learned about the benefits and risks of non-prescription availability?. Health Policy. (Systematic review of literature and adverse event reporting on nicotine replacement therapy, which has been marketed "without incident as a non-prescription product in 33 countries...").
Moore D, Aveyard P, Connock M, Wang D, Fry-Smith A, Barton P. (2009). Effectiveness and safety of nicotine replacement therapy assisted reduction to stop smoking: systematic review and meta-analysis. BMJ. (Systematic review of literature on efficacy and safety of nicotine replacement therapy for smoking cessation; no serious adverse events were attributed to nicotine therapy; no mention of liver injury or ALT levels).
Ossip DJ, Abrams SM, Mahoney MC, Sall D, Cummings KM. (2009). Adverse effects with use of nicotine replacement therapy among quitline clients. Nicotine Tob Res. (Follow up interviews were conducted on 33,690 smokers who were given nicotine replacement therapy; 25% reported adverse events, but these were largely nonspecific and mild, without mention of liver injury).
(2009). Safety of smoking cessation drugs. Med Lett Drugs Ther. (Concise review of safety of medications used for smoking cessation; nicotine replacement therapy is not discussed).
McNeil JJ, Piccenna L, Ioannides-Demos LL. (2010). Smoking cessation-recent advances. Cardiovasc Drugs Ther. (Review of mechanisms of action, efficacy and safety of smoking cessation therapies; hepatotoxicity is not discussed).
Bullen C, Howe C, Laugesen M, McRobbie H, Parag V, Williman J, Walker N. (2013). Electronic cigarettes for smoking cessation: a randomised controlled trial. Lancet. (Among 657 adult smokers treated for smoking cessation for 12 weeks, confirmed abstinence rates at 24 weeks was 5.8% for a nicotine patch, 7.3% for e-cigarettes and 4.3% for placebo e-cigarettes; adverse event rates were similar across groups and there were no serious adverse events attributed to the interventions).
Hajek P, Etter JF, Benowitz N, Eissenberg T, McRobbie H. (2014). Electronic cigarettes: review of use, content, safety, effects on smokers and potential for harm and benefit. Addiction. (Review of the use, content, efficacy and safety of e-cigarettes concludes that they are a reasonable option for smokers unable to quit using conventional approaches, as a safer alternative to smoking and a possible pathway to complete cessation).
Pisinger C, Døssing M. (2014). A systematic review of health effects of electronic cigarettes. Prev Med. (Systematic review of the literature identified 74 articles on health effects of e-cigarettes some focusing upon ingredients showing variability in concentrations of nicotine, propylene glycol and low levels of nitrosamines, formaldehyde, toluene, chromium and cinnamon, the products frequently showing cytotoxicity in cell culture systems; human studies being few and frequently biased; the authors concluded that e-cigarettes could hardly be considered harmless).
Crowley RA, Health Public Policy Committee of the American College of Physicians. (2015). Electronic nicotine delivery systems: executive summary of a policy position paper from the American College of Physicians. Ann Intern Med. (Recommendations regarding e-cigarettes from the American College of Physicians include that they be regulated by the FDA, that flavoring be banned, that they be taxed to discourage use, that their promotion be regulated, that their use be restricted in public places and that increased funding be given to research on their safety).
Kaisar MA, Prasad S, Liles T, Cucullo L. (2016). A decade of e-cigarettes: limited research & unresolved safety concerns. Toxicology. (Review of the safety of e-cigarettes, a decade after they first became available during which there has been a marked increase in their use particularly among teenagers).
Walele T, Sharma G, Savioz R, Martin C, Williams J. (2016). A randomised, crossover study on an electronic vapour product, a nicotine inhalator and a conventional cigarette. Part B: Safety and subjective effects. Regul Toxicol Pharmacol. (Short term study of safety of electronic vapor nicotine delivery system compared to conventional cigarettes and a nicotine inhalator found no serious adverse events and similar tolerance among the various products tested).
Dinakar Ch, O’Connor GT. (2016). The health effects of electronic cigarettes. N Engl J Med. (Review of the health benefits and risks of e-cigarettes whether used short term as a smoking cessation aid or long term as a smoking replacement; no mention of liver injury).
Breland A, Soule E, Lopez A, Ramôa C, El-Hellani A, Eissenberg T. (2017). Electronic cigarettes: what are they and what do they do?. Ann N Y Acad Sci. (Review of the design of commercially available e-cigarettes, their ingredients, clinical efficacy in smoking cessation, problems of use in previous nonsmokers and laboratory evidence for effects on respiratory, cardiovascular and immune function; no mention of hepatic effects).
Canistro D, Vivarelli F, Cirillo S, Babot Marquillas C, Buschini A, Lazzaretti M, Marchi L, et al. (2017). E-cigarettes induce toxicological effects that can raise the cancer risk. Sci Rep. (Studies of vapor from e-cigarettes in a rat model found evidence that they can induce potentially harmful bioactivating enzymes in lung, with formation of reactive oxygen species, DNA oxidation and DNA strand breaks suggesting that e-cigarettes may have carcinogenic effects).
Manzoli L, Flacco ME, Ferrante M, La Vecchia C, Siliquini R, Ricciardi W, Marzuillo C, et al., ISLESE Working Group. (2017). Cohort study of electronic cigarette use: effectiveness and safety at 24 months. Tob Control. (Follow up of 24 months found rates of not smoking to be 61% among smokers who switched to e-cigarettes, 23% among smokers who did not use e-cigarettes and 25% among those who used both, with no differences in adverse event rates).
(2019). Drugs for smoking cessation. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy and safety of drugs used for smoking cessation mentions that e-cigarettes are not approved for use in smoking cessation by the FDA and that their potential for causing long term adverse effects is not known).
Hajek P, Phillips-Waller A, Przulj D, Pesola F, Myers Smith K, Bisal N, Li J, et al. (2019). A randomized trial of e-cigarettes versus nicotine-replacement therapy. N Engl J Med. (Among 886 who wanted to stop smoking and were randomized to nicotine replacement therapy or e-cigarettes, smoking abstinence at 12 months was 10% vs 18%, but 80% of the e-cigarette compared to only 9% of the nicotine replacement group were still using the product; no mention of ALT elevations or hepatotoxicity).
Civiletto CW, Aslam S, Hutchison J. Electronic delivery (vaping) of cannabis and nicotine. November 10, 2019. StatPearls [Internet]. Treasure Island (FL): StatPearls Publishing; 2020. http://www.ncbi.nlm.nih.gov/books/NBK545160/ (Review of modern electronic cigarette design, their increasing use, effects and safety focusing upon acute and chronic lung injury).
Blount BC, Karwowski MP, Shields PG, Morel-Espinosa M, Valentin-Blasini L, Gardner M, Braselton M, et al., Lung Injury Response Laboratory Working Group. (2020). Vitamin E acetate in bronchoalveolar-lavage fluid associated with EVALI. N Engl J Med. (Analysis of bronchial lavage samples from 50 patients with severe e-cigarette vaping associated lung injury revealed vitamin E acetate in 41, suggesting that aerosolization of the solvent was responsible for the tissue injury).

## OTHER REFERENCE LINKS

1 Recent References on Nicotine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Nicotine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Nicotine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Nicotine)